# Fingolimod

## OVERVIEW

### Introduction

Fingolimod is an orally available sphingosine-1-phosphate (S1P) receptor modulator that acts as an immunomodulatory drug and is used to treat relapsing multiple sclerosis. Fingolimod is associated with transient serum enzyme elevations during therapy and with rare instances of clinically apparent, acute liver injury that can be severe and even fatal.

### Background

Fingolimod (fin gol' i mod) is an orally available sphingosine-1-phosphate (S1P) receptor modulator that acts as an immunomodulatory drug and is used to treat relapsing multiple sclerosis in adults. Fingolimod is a derivative of myriocin, a metabolite of the fungus Isaria sinclairii and is a structural analogue of sphingosine. Once phosphorylated intracellularly, fingolimod acts as a sphingosine-1-phosphate receptor modulator which renders T and B cells insensitive to signals necessary for egress from lymphoid tissue. In animal models of multiple sclerosis, fingolimod resulted in reduced recirculation of autoaggressive lymphocytes to the central nervous system. Subsequently, in several large, randomized controlled trials, fingolimod was shown to reduce relapse rates and improve neuro-radiologic outcomes in adult patients with relapsing-remitting multiple sclerosis. Fingolimod was approved for use in relapsing multiple sclerosis in the United States in 2010 and was the first oral, disease modifying agent approved in this condition. Fingolimod is available in capsules of 0.25 and 0.5 mg generically and under the brand name Gilenya. The recommended dose in adults is 0.5 mg orally once daily. Common side effects are lymphopenia, headache, diarrhea, cough, shortness of breath, increase in blood pressure, bradycardia, rhinorrhea and back and abdominal pain. Rare, but potentially severe adverse events include viral, bacterial and fungal opportunistic infections, atrial arrhythmias, bradycardia and heart block, pulmonary disfunction, liver injury, macular edema, progressive multifocal leukoencephalopathy (PML), posterior reversible encephalopathy syndrome (PRES), acute hypersensitivity reactions, embryonal and fetal toxicity, and an increased risk for basal cell and melanoma skin cancers and lymphoma.

### Hepatotoxicity

In large randomized controlled trials of fingolimod in patients with multiple sclerosis, serum ALT elevations above 3 times ULN were reported in 8% to 14% of fingolimod compared to 2% to 3% of placebo recipients. ALT elevations above 5 times ULN occurred in 4.5% with fingolimod vs 1% with placebo. The enzyme elevations were usually transient and not associated with symptoms or jaundice and required drug discontinuation in less than 1% of cases. No instances of acute hepatitis or clinically apparent liver injury were reported in the preregistration trials of fingolimod. Subsequent to its approval and more wide scale use, however, instances of clinically apparent liver injury attributed to fingolimod were reported including cases of acute liver failure requiring emergency liver transplantation. The onset of liver injury was often within days or weeks of starting treatment and the pattern of liver enzyme elevations was usually hepatocellular. For these reasons, patients should be evaluated for liver disease and monitored for liver test abnormalities before starting treatment and regularly during and for two months after discontinuing therapy. In addition, at least one instance of reactivation of hepatitis B in an inactive HBsAg carrier has been reported and pre-screening for markers of HBV infection is also recommended. Thus, mild-to-moderate and transient serum enzyme elevations during therapy are not uncommon, and clinically apparent liver injury with jaundice due to fingolimod can occur.

Likelihood score: C (probable cause of clinically apparent liver injury as well as reactivation of hepatitis B in susceptible patients).

### Mechanism of Injury

The mechanism by which fingolimod might cause liver injury is not known. It is extensively metabolized by liver via the cytochrome P450 system, predominantly CYP 4F2, and liver injury may be caused by a toxic or immunogenic intermediate of its metabolism. Despite its interaction with the P450 system, drug-drug interactions are not common. Reactivation of hepatitis B appears to be uncommon, but is likely caused by the lymphopenia and immunosuppression induced by fingolimod.

### Outcome and Management

Chronic therapy with fingolimod is associated with mild-to-moderate serum aminotransferase elevations in approximately 10% of patients, and clinically apparent liver injury has occurred with its use, usually shortly after initiation of treatment. Because of the frequency of enzyme elevations detected during therapy and subsequent reports of clinically apparent liver injury, the FDA now recommends that routine liver tests be done before initiation of treatment and then repeated regularly thereafter until at least 2 months after stopping. More frequent monitoring is recommended if serum enzyme levels rise above 3 times the upper limit of normal (ULN) and therapy discontinued if there are symptoms or signs of liver injury or jaundice or if aminotransferase levels rise above 5 times ULN. Because fingolimod can cause reactivation of hepatitis B, patients should be screened for evidence of HBV infection before starting therapy and given prophylaxis if HBsAg positive, or monitored with testing for HBV DNA as evidence of reactivation, and started on antiviral therapy if HBV DNA becomes detectable. There is no known cross sensitivity of the hepatic injury from fingolimod with other agents used to treat multiple sclerosis, but similar liver injury has been reported with other S1P receptor modulators such as siponimod, ozanimod and ponesimod, which may manifest some degree of cross sensitivity.

Drug Class: Multiple Sclerosis Agents

Other Drugs in the Subclass, S1P Receptor Modulators: Ozanimod, Ponesimod, Siponimod

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fingolimod – Generic, Gilenya®

DRUG CLASS

Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fingolimod)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Fingolimod | 162359-55-9 | C19-H33-N-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 25 November 2025

Abbreviations: AMA, antimitochondrial antibody; HBV, hepatitis B virus; S1P, sphingosine-1-phosphate.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 697-8. (Expert review of hepatotoxicity published in 1999 before the availability of fingolimod).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss the drugs for multiple sclerosis).
Krensky AM, Bennett WM, Vincenti F. A case study: immunotherapy for multiple sclerosis. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1025-7. (Textbook of pharmacology and therapeutics).
European Medicines Agency. Direct Healthcare Professional Communication. 2020. https://www.ema.europa.eu/en/documents/dhpc/direct-healthcare-professional-communication-dhpc-gilenya-fingolimod-updated-recommendations_en.pdf (EMA communication reporting 3 cases of acute liver failure requiring emergency liver transplantation in patients taking fingolimod, with recommendations on monitoring of liver tests at regular intervals).
Kappos L, Radue EW, O'Connor P, Polman C, Hohlfeld R, Calabresi P, Selmaj K, et al.; FREEDOMS Study Group. A placebo-controlled trial of oral fingolimod in relapsing multiple sclerosis. N Engl J Med 2010; 362: 387-401. (Among 1272 patients with relapsing multiple sclerosis treated with fingolimod [0.5 or 1.25 mg daily] or placebo for 24 months, 8.5-12.5% of fingolimod, but only 1.7% of placebo recipients developed ALT elevations above 3 times ULN, and ALT levels fell to normal with or without discontinuation, and serum bilirubin levels did not change). 20089952
Cohen JA, Barkhof F, Comi G, Hartung HP, Khatri BO, Montalban X, Pelletier J, et al.; TRANSFORMS Study Group. Oral fingolimod or intramuscular interferon for relapsing multiple sclerosis. N Engl J Med 2010; 362: 402-15. (Among 1280 patients with relapsing multiple sclerosis treated with fingolimod [0.5 or 1.25 mg daily] or interferon beta [30 mg weekly] for 12 months, relapse rates were lower, but ALT elevations above 3 times ULN were more common with fingolimod [7% and 8%] than interferon beta [2%], although there were no episodes of clinically apparent liver injury). 20089954
Oral fingolimod (gilenya) for multiple sclerosis. Med Lett Drugs Ther 2010; 52 (1353-1354): 98-9. (Concise review of mechanism of action, efficacy, safety and costs of fingolimod shortly after is approval for use for multiple sclerosis in the US, mentions that common side effects are headache, cough, diarrhea, back pain and aminotransferase elevations; no mention of clinically apparent liver injury). 21344782
Gold R. Oral therapies for multiple sclerosis: a review of agents in phase III development or recently approved. CNS Drugs 2011; 25: 37-52. (Review of oral medications for multiple sclerosis under development including dimethyl fumarate [BG-12], fingolimod, teriflunomide, laquinimod and cladribine). 21128693
Killestein J, Rudick RA, Polman CH. Oral treatment for multiple sclerosis. Lancet Neurol 2011; 10: 1026-34. (Review of the clinical usefulness and safety of 5 new oral therapies for relapsing multiple sclerosis mentions that liver enzyme elevations can occur with teriflunomide and fingolimod therapy). 22014437
New drugs for relapsing multiple sclerosis. Med Lett Drugs Ther 2012; 54 (1403): 89-91. (Concise review of efficacy, safety and costs of new disease modifying drugs for multiple sclerosis lists side effects in a table including "transaminase elevations" for interferon beta, fingolimod and teriflunomide and "hepatotoxicity" for natalizumab, but not for glatiramer or mitoxantrone). 23183318
Oh J, O'Connor PW. Safety, tolerability, and efficacy of oral therapies for relapsing-remitting multiple sclerosis. CNS Drugs 2013; 27: 591-609. (Review of efficacy and safety or oral agents for multiple sclerosis, including fingolimod, teriflunomide, dimethyl fumarate, laquinimod and cladribine, none of which have raised major issues of hepatotoxicity). 23801528
Pawate S, Bagnato F. Newer agents in the treatment of multiple sclerosis. Neurologist 2015; 19: 104-17. (Summary of the efficacy and safety of new drugs for multiple sclerosis mentions that fingolimod, laquinimod and teriflunomide have been associated with serum enzyme elevations during treatment, but no specifics given). 25888198
Kappos L, Cohen J, Collins W, de Vera A, Zhang-Auberson L, Ritter S, von Rosenstiel P, et al. Fingolimod in relapsing multiple sclerosis: an integrated analysis of safety findings. Mult Scler Relat Disord 2014; 3: 494-504. (Analysis of safety findings in multiple phase 2 and 3 studies of fingolimod for multiple sclerosis involving 3553 patients in 4 trials and subsequent 24 month extension studies; ALT elevations above 3 times ULN occurred in 8.5-12.5% of fingolimod vs 1.7% of placebo recipients and were greater than 10 times ULN in 0.2-0.4% [vs 0%], but "there were no cases of severe drug-induced hepatotoxicity during clinical trials or in the post-marketing setting"). 25877062
Ward MD, Jones DE, Goldman MD. Overview and safety of fingolimod hydrochloride use in patients with multiple sclerosis. Expert Opin Drug Saf 2014; 13: 989-98. (Review of efficacy and safety of fingolimod from multiple phase 2 and 3 trials in multiple sclerosis lists elevated liver tests as occurring in 15.8% of fingolimod vs 5% of placebo recipients in one trial and 6.5% vs 1.9% in a second, but that the elevations "resolved spontaneously with or without discontinuation"). 24935480
Kappos L, O’Connor P, Radue E-W, Polman C, Hohlfeld R, Selmaj K, Ritter S, et al. Long-term effects of fingolimod in multiple sclerosis: the randomized FREEDOMS extension trial. Neurology 2015; 84: 1582-91. (Among 920 patients with multiple sclerosis enrolled in an extension study of fingolimod [0.5 vs 1.25 mg daily], beneficial effects were sustained and no new safety concerns arose, serum enzyme elevations occurring in 13% and 19% of subjects during the first and 7% and 8% during the second year of fingolimod therapy). 25795646
English C, Aloi JJ. New FDA-approved disease-modifying therapies for multiple sclerosis. Clin Ther 2015; 37: 691-715. (Systematic review of efficacy and safety of the newer disease modifying therapies of multiple sclerosis lists ALT elevations as adverse events associated with fingolimod, teriflunomide and dimethyl fumarate, but not peginterferon beta or alemtuzumab). 25846320
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 [0.8%] were attributed to interferon beta, but none were linked to fingolimod or other drugs used for multiple sclerosis). 25754159
Feinstein A, Freeman J, Lo AC. Treatment of progressive multiple sclerosis: what works, what does not, and what is needed. Lancet Neurol 2015; 14: 194-207. (Commentary on management of progressive multiple sclerosis in which most of the new, disease modifying agents have little effect, mentions that major attention should be paid to management and relief of symptoms such as fatigue, bladder dysfunction, spasticity, pain, depression and cognitive dysfunction; no discussion of liver related adverse effects). 25772898
Yamout BI, Zeineddine MM, Tamim H, Khoury SJ. Safety and efficacy of fingolimod in clinical practice: The experience of an academic center in the Middle East. J Neuroimmunol 2015; 289: 93-7. (Among 122 patients with multiple sclerosis treated with fingolimod at a Lebanese referral center between 2011 and 2015, adverse events included ALT or AST elevations in 25% of patients which were above 3 times ULN in 4%, but did not result in clinically apparent liver injury or require drug discontinuation). 26616877
Memon A, Miranda J. Hepatitis E virus infection in a patient with suspected drug-induced liver injury. BMJ Case Rep 2017; 2017. pii: bcr2016218387. (58 year old Irish woman with multiple sclerosis developed hepatitis 3 months after switching from interferon beta to fingolimod [peak bilirubin 16.1 mg/dL, ALT 2722 U/L, Alk P 158 U/L], subsequently found to be unrelated to fingolimod and due to acute hepatitis E). 28143860
Marrone A, Signoriello E, Alfieri G, Dalla Mora L, Rinaldi L, Rainone I, Adinolfi LE, et al. Epstein Barr virus infection reactivation as a possible trigger of primary biliary cirrhosis-like syndrome in a patient with multiple sclerosis in the course of fingolimod treatment. Infez Med 2014; 22: 331-6. (34 year old man with relapsing multiple sclerosis developed elevations in ALT and GGT after starting fingolimod that were preceded by a viral like syndrome and finding of IgM anti-EBV suggestive of reactivation, and was later found to be AMA positive and with the likely diagnosis of primary biliary cirrhosis which responded to stopping fingolimod and starting ursodiol therapy). 25551852
Berger B, Baumgartner A, Rauer S, Mader I, Luetzen N, Farenkopf U, Stich O. Severe disease reactivation in four patients with relapsing-remitting multiple sclerosis after fingolimod cessation. J Neuroimmunol 2015; 282: 118-22. (Description of 4 patients who were treated with fingolimod for relapsing-remitting multiple sclerosis for 2 months to 6 years during which the disease was stable, and then had flare of the multiple sclerosis within 2-4 months of stopping). 25903738
Rojas JI, Patrucco L, Miguez J, Cristiano E. Real-world safety and patient profile of fingolimod in relapsing-remitting multiple sclerosis: a prospective analysis in Buenos Aires, Argentina. Clin Neuropharmacol 2017; 40: 251-4. (Among 145 Argentinian adults with multiple sclerosis treated with fingolimod for an average of 2 years, 11 [8%] had ALT elevations during therapy but all were transient and benign, and none developed symptoms or jaundice). 28976408
Filippi M, Bar-Or A, Piehl F, Preziosa P, Solari A, Vukusic S, Rocca MA. Multiple sclerosis. Nat Rev Dis Primers 2018; 4: 43. (Review of the pathogenesis, clinical features, natural history, management and therapy of multiple sclerosis). 30410033
Antonazzo IC, Poluzzi E, Forcesi E, Riise T, Bjornevik K, Baldin E, Muratori L, et al. Liver injury with drugs used for multiple sclerosis: A contemporary analysis of the FDA Adverse Event Reporting System. Mult Scler 2019; 25: 1633-40. (Analysis of reports of liver injury to the FDA Adverse Events Reporting System between 2004 and 2016 suggested that the disease modifying agents for multiple sclerosis that appear to have hepatotoxic potential include interferon beta, teriflunomide, fingolimod, mitoxantrone and alemtuzumab, whereas glatiramer, dimethyl fumarate and natalizumab do not). 30230957
Swallow E, Patterson-Lomba O, Yin L, Mehta R, Pelletier C, Kao D, Sheffield JK, et al. Comparative safety and efficacy of ozanimod versus fingolimod for relapsing multiple sclerosis. J Comp Eff Res 2020; 9: 275-85. (Analysis of individual patient data from trials of ozanimod [n=1773] and fingolimod [n=1212] with adjustments found that adverse events were less frequent with ozanimod, including ALT elevations above 3 times ULN [-3%]). 31948278
Lu MC, Shih YL, Hsieh TY, Lin JC. Flare of hepatitis B virus after fingolimod treatment for relapsing and remitting multiple sclerosis. J Formos Med Assoc 2020; 119: 886-7. (Letter describing 41 year old Taiwanese woman with relapsing multiple sclerosis and inactive HBsAg carrier state who developed reactivation of hepatitis B after 35 months of treatment with fingolimod [ALT 385 U/L, HBV DNA 8 log_10_ IU/mL, bilirubin not given], who responded to tenofovir with resolution of ALT elevations and decrease of HBV DNA levels to undetectable despite continuation of fingolimod). 31679907
Drugs for multiple sclerosis. Med Lett Drugs Ther 2021; 63(1620): 42-8. (Concise review of the relative clinical efficacy, safety and costs of drugs for relapsing multiple sclerosis including parenteral agents [such as interferon-beta, glatiramer acetate, natalizumab, alemtuzumab, ocrelizumab, ofatumumab, rituximab and mitoxantrone] and the oral agents [such as the S1P receptor modulators, cladribine, fumarates, and teriflunomide], many of which are associated with serum ALT elevations and several have been reported to cause clinically apparent liver injury or reactivation of hepatitis B). 33976089
Yang CC, Ro LS, Tsai NW, Lin CC, Huang WN, Tsai CP, Lin TS, et al. Real-world evidence on the safety and effectiveness of fingolimod in patients with multiple sclerosis from Taiwan. J Formos Med Assoc 2021; 120: 542-50. (Among 69 Taiwanese adults with relapsing multiple sclerosis who were started on fingolimod [0.5 mg daily] between 2012 and 2015, 62 remained on therapy and adverse events were mostly mild-to-moderate in severity: bradycardia [22%], dizziness [12%], numbness [12%] and back pain [7%] being most common; 7 persons had liver enzyme elevations but only two had ALT elevations above 5 times ULN, both of which were transient, asymptomatic and did not require discontinuation). 32669233
McGinley MP, Cohen JA. Sphingosine 1-phosphate receptor modulators in multiple sclerosis and other conditions. Lancet 2021;398(10306):1184-94.. (Review of the function of S1P receptors and the mechanism of action of S1P receptor modulators in affecting lymphocyte tracking out of lymph nodes into the circulation and tissues; fingolimod is a nonspecific modulator affecting S1P receptors 1, 3, 4 and 5, whereas siponimod and ozanimod act predominantly on S1P receptors 1 and 5 and ponesimod against S1P receptor-1 alone, the activity against S1P receptor-1 accounting for most of the beneficial effects in multiple sclerosis and the restricted specificity perhaps accounting for the lower rate of cardiac, lung and eye adverse events, driven mostly by the inhibition of the other S1P receptor subtypes). 34175020
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for multiple sclerosis, mentions that in controlled trials, fingolimod therapy was associated with abnormal liver test elevations in 11% of patients that were above 5 times ULN in 2%, while cases of clinically apparent liver injury were not reported, but that since its approval several cases including 3 cases of acute liver failure leading to emergency liver transplantation have been reported, as have examples of reactivation of hepatitis B and C, so that frequent monitoring of liver tests is recommended). 34319570
Caliskan AR, Muhip Harputluoglu MM, Samdanci E, Cirik S, Yilmaz S. Fingolimod induced fulminant liver failure requiring liver transplantation: A case report. Hepatol Forum. 2023;4:74-77.. (33 year old woman with multiple sclerosis and history of hepatotoxicity from interferon beta developed fatigue after 12 days and abnormal liver tests at 14 days after starting fingolimod [bilirubin 36.7 mg/dL, ALT 517 U/L, Alk P 128 U/L, INR 3.7] with progressive liver failure and transplantation 9 days later, the explant showing massive necrosis). 37250929
Ng HS, Zhu F, Zhao Y, Yao S, Lu X, Ekuma O, Evans C, et al. Adverse events associated with disease-modifying drugs for multiple sclerosis: a multiregional population-based study. Neurology. 2024;102:e208006.. (Among 35,894 people from 4 Canadian provinces with multiple sclerosis and available health data there was an increased risk for incident cardio- and cerebral-vascular events among those taking fingolimod but no significant increase in rates of acute or chronic liver disease, the numbers of cases being perhaps too small to demonstrate a difference). 38181306
García Calonge M, García Martínez M, García Ramos M, Oterino Durán A, Riera JR, Rodríguez M. Overlap autoimmune hepatitis and primary sclerosing cholangitis in a patient with multiple sclerosis. Rev Esp Enferm Dig. 2025 Jan 20. Epub ahead of print.. (17 year old boy with multiple sclerosis developed liver test elevations 13 months after starting fingolimod [bilirubin 0.5 mg/dL, ALT 321 U/L, Alk P 787 U/L, GGT 737 U/L], but with little improvement on stopping drug and autoimmune features [ANA 1:320, IgG 1823 mg/dL] and liver biopsy with features of both sclerosing cholangitis and autoimmune hepatitis, and subsequent improvement with corticosteroids, natalizumab, and ursodiol). 39831609
Signoriello E, Romano G, Foschi M, Zanghì A, D'Amico E, Fantozzi R, Centonze D, et al. Switch from fingolimod to ozanimod for safety or intolerance reasons. Ther Adv Neurol Disord. 2025;18:17562864251328191.. (Among 13 patients with multiple sclerosis who were switched from fingolimod to ozanimod because of aminotransferase elevations, all tolerated therapy without recurrence of enzyme elevations in 7 and with lesser degrees of liver test abnormalities in the remainder). 40655996
Sönmez MT, Yetkin MF, Mehdiyev DA, Köseoğlu M, Mungan S, Kale N, Terzi M, et al. Safety and efficacy of cladribine in patients discontinuing fingolimod due to elevated transaminase levels: The FinClad Study. Mult Scler Relat Disord. 2025;101:106578.. (Among 45 patients with multiple sclerosis who switched from fingolimod to cladribine therapy because of serum aminotransferase elevations, both ALT and AST fell into the normal range in all patients and 87% “maintained effective disease control”). 40570400
Abbadessa G, Schiavetti I, Bollo L, Cellerino M, Miele G, Zanghì A, Cavalla P, et al; S1PRm study group. Safety assessment of switching from fingolimod to siponimod: An Italian multicenter prospective study. J Neurol Sci. 2025;474:123533. 40373481. (Among 95 Italian patients with secondary progressive multiple sclerosis on fingolimod, 42 were switched to siponimod, after which ALT elevations were found in 33% of those on Siponimod vs 21% remaining on fingolimod, but there were no elevations above 5 times ULN).

## OTHER REFERENCE LINKS

1. Recent References on Fingolimod: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Fingolimod+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Fingolimod: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fingolimod)